# Black Cumin Seed

## OVERVIEW

### Introduction

Black cumin also known as black seed and Nigella sativa is a flowering plant native to Eastern Europe and the Middle East that produces black seeds which are used to produce spice and flavoring of food and have been used in traditional medicine as therapy for a wide variety of conditions. Black cumin is well tolerated, is generally recognized as safe and has not been associated with serum enzyme elevations during therapy nor implicated in cases of clinically apparent liver injury.

### Background

Black Cumin (Nigella sativa) is a flowering annual plant native to Eastern Europe and the Middle East that is now cultivated in many areas of world and produces a black seed, extracts of which are used as a spice and for flavoring foods. In addition to its culinary uses, black cumin seeds and their extracts have also been used extensively in traditional medicine for multiple conditions including constipation, dyspepsia, ulcer disease, fever, cough, bronchitis, headaches, hypertension, gout, arthritis, heart disease, toothache, back pain, skin disease, and wounds. Claims have been made that black cumin seed extracts and oils have antioxidant, antiinflammatory, antineoplastic, antihypertensive, antidiabetic, cholesterol lowering, immunomodulatory, cardioprotective, neuroprotective, nephroprotective, and even hepatoprotective properties. Indeed, a famous comment is: “the black cumin is healing for all diseases except death.” These purported effects, while shown in vitro in cell culture and in vivo in animal experiments have not been consistently demonstrated in clinical trials in humans. Black cumin seeds have multiple phytoconstituents including a high concentration of elemental oils such as linoleic acid, oleic acid, palmitic acid and several volatile oils such as thymoquinone, the suspected major bioactive component. In small, placebo controlled clinical trials in patients with hyperlipidemia, black cumin extracts and thymoquinone were associated with a slight decrease in LDL cholesterol and triglyceride levels and increase in HDL cholesterol levels. In trials in patients with type 2 diabetes, black cumin extracts and oils have been found to have a modest salutary effect on hemoglobin A1c and postprandial blood glucose levels. Similarly, in trials in patients with systemic arterial hypertension, black cumin extracts had a modest favorable effect on systolic and diastolic blood pressure. The overall evidence for clinical benefit of these effects, however, is not very convincing. Neither black cumin seed extracts nor concentrated thymoquinone oils have been approved as therapy for hyperlipidemia, diabetes, hypertension or any other medical disease or condition by the FDA. Black cumin extracts remain available over-the-counter as a dietary supplement in multiple forms including liquid, powders and capsules purported to be helpful for digestive health and to boost energy. The typical recommended dose is 300 to 1000 mg taken one to two times daily. Extracts and oils from black cumin seeds have consistently been found to be well tolerated and safe and the FDA lists black cumin spice as “generally recognized as safe” (GRAS). Side effects can include abdominal discomfort, bloating, dysgeusia, diarrhea, and headache, but these effects are generally transient and mild. Rare, potentially severe adverse events include rash and hypersensitivity reactions.

### Hepatotoxicity

In multiple, largely short term clinical studies of different preparations and concentrations of black cumin seed powdered extracts and oils, adverse side effects were usually described as uncommon and mild with either no change or slight improvement in serum aminotransferase and alkaline phosphatase levels. Furthermore, black cumin products have been used to treat liver diseases including nonalcoholic fatty liver and chronic hepatitis C without evidence of disease worsening during therapy. Despite widespread use, there have been no published reports of serum enzyme elevations or clinically apparent liver injury attributable to products containing black cumin seed.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism by which black cumin seed extracts might cause liver injury is unknown.

### Outcome and Management

Hepatotoxicity from extracts of black cumin seeds has not been reported.

Drug Class: Herbal and Dietary Supplements

Other names: Black seed, Black caraway, Small fennel, Fennel flower, Roman Coriander, Nigella, Nigella sativa.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Black Cumin – Generic

DRUG CLASS

Herbal and Dietary Supplements

SUMMARY INFORMATION

Fact Sheet at MedlinePlus, NLM (https://medlineplus.gov/druginfo/natural/901.html)

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Black Cumin | 90064-32-7 (https://pubchem.ncbi.nlm.nih.gov/substance/135353902) | Herbal | Not Applicable
Thymoquinone | 490-91-5 | Volatile Oil

## ANNOTATED BIBLIOGRAPHY

References updated: 27 April 2023

Abbreviations: HDS, herbal and dietary supplements.

Zimmerman HJ. Unconventional drugs. Miscellaneous drugs and diagnostic chemicals. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott,1999: pp. 731-4. (Expert review of hepatotoxicity published in 1999; several herbal medications are discussed, but not black cumin seed oils or extracts).
Liu LU, Schiano TD. Hepatotoxicity of herbal medicines, vitamins and natural hepatotoxins. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 2nd ed. New York: Informa Healthcare USA, 2007, pp. 733-54. (Review of hepatotoxicity of herbal and dietary supplements [HDS] published in 2007; no mention of black cumin).
Qidwai W, Hamza HB, Qureshi R, Gilani A. (2009). Effectiveness, safety, and tolerability of powdered Nigella sativa (kalonji) seed in capsules on serum lipid levels, blood sugar, blood pressure, and body weight in adults: results of a randomized, double-blind controlled trial. J Altern Complement Med. (Among 123 Pakistani adults with hypercholesterolemia treated with black cumin powdered extract [1 gm] or placebo twice daily for 6 weeks, only 73 completed the trial in whom there were minimal changes in LDL cholesterol or triglycerides levels and no changes in serum ALT; no mention of adverse events).
Jacobsson I, Jönsson AK, Gerdén B, Hägg S. (2009). Spontaneously reported adverse reactions in association with complementary and alternative medicine substances in Sweden. Pharmacoepidemiol Drug Saf. (Review of 778 spontaneous reports of adverse reactions to herbals in a Swedish Registry does not list black cumin among products associated with 5 or more reports).
Reuben A, Koch DG, Lee WM, Acute Liver Failure Study Group. (2010). Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 [11%] were attributed to drug induced liver injury of which 12 [9%] were due to herbals, including several herbal mixtures, usnic acid, Ma Huang, black cohosh, and Hydroxycut, but not black cumin).
Teschke R, Wolff A, Frenzel C, Schulze J, Eickhoff A. (2012). Herbal hepatotoxicity: a tabular compilation of reported cases. Liver Int. (A systematic compilation of all publications on the hepatotoxicity of specific herbals identified 185 publications on 60 different herbs, herbal drugs and supplements, but does not mention or list black cumin extracts or oils).
Barakat EM, El Wakeel LM, Hagag RS. (2013). Effects of Nigella sativa on outcome of hepatitis C in Egypt. World J Gastroenterol. (Among 30 Egyptian adults with chronic hepatitis C treated with black cumin [450 mg] or placebo oil thrice daily for 3 months, fasting blood glucose levels improved [104 to 92 mg/dL], but ALT levels did not [35 to 41 U/L], and HCV RNA levels decreased slightly [5.6 to 5.2 log_10_ copies/mL], while adverse events included gastritis [n=1] and hypoglycemia [n=5] but no acute liver injury or hepatic decompensation).
Bunchorntavakul C, Reddy KR. (2013). Review article: herbal and dietary supplement hepatotoxicity. Aliment Pharmacol Ther. (Systematic review of literature on HDS associated liver injury does not mention black cumin).
Navarro VJ, Seeff LB. (2013). Liver injury induced by herbal complementary and alternative medicine. Clin Liver Dis. (Review of the epidemiology, regulatory status, diagnosis, pathogenesis and causes of liver injury from herbal products with specific discussion of conjugated linoleic acid, ephedra, germander, green tea, usnic acid, flavocoxid, aloe vera, chaparral, greater celandine, black cohosh, comfrey, kava, skullcap, valerian, noni juice, pennyroyal and traditional herbal remedies).
Navarro VJ, Barnhart H, Bonkovsky HL, Davern T, Fontana RJ, Grant L, Reddy KR, et al. (2014). Liver injury from herbals and dietary supplements in the U.S. Drug-Induced Liver Injury Network. Hepatology. (Among 839 cases of liver injury from drugs collected in the US between 2004 and 2013, 130 were due to HDS products, including 45 from body building agents [probably anabolic steroids] and 85 from diverse HDS products but no case was attributed specifically to black cumin extract).
Mohtashami R, Huseini HF, Heydari M, Amini M, Sadeqhi Z, Ghaznavi H, Mehrzadi S. (2015). Efficacy and safety of honey based formulation of Nigella sativa seed oil in functional dyspepsia: A double blind randomized controlled clinical trial. J Ethnopharmacol. (Among 70 Iranian adults with functional dyspepsia treated with black cumin oil vs placebo for 8 weeks, index of dyspepsia scores improved more with black cumin that placebo [-12 vs -3] as did quality of life scores, and mild adverse events occurred in similar proportion of the two groups; no mention of ALT levels or hepatotoxicity).
Sahebkar A, Beccuti G, Simental-Mendía LE, Nobili V, Bo S. (2016). Nigella sativa (black seed) effects on plasma lipid concentrations in humans: A systematic review and meta-analysis of randomized placebo-controlled trials. Pharmacol Res. (Systematic review identified 17 randomized controlled trials of black cumin formulations for effect of serum lipid levels, the combined results demonstrating differences with placebo in decreases in total cholesterol of -15.6 mg/dL, LDL cholesterol of -14.1 mg/dL and triglycerides of -20.6 mg/dL with little effect on HDL cholesterol levels, the overall effects being more convincing with black cumin oil than with powdered extracts).
Sahebkar A, Soranna D, Liu X, Thomopoulos C, Simental-Mendia LE, Derosa G, Maffioli P, et al. (2016). A systematic review and meta-analysis of randomized controlled trials investigating the effects of supplementation with Nigella sativa (black seed) on blood pressure. J Hypertens. (Systematic review identified 11 randomized controlled trials [in 860 adults] of black cumin for its effects on blood pressure, found differences of -3.3 mmHg in systolic and -2.8 mmHg in diastolic blood pressure between black cumin and placebo or standard therapy after an average of 8 weeks).
Brown AC. (2017). Liver toxicity related to herbs and dietary supplements: Online table of case reports. Part 2 of 5 series. Food Chem Toxicol. (Description of an online compendium of cases of liver toxicity attributed to HDS products does not list or discuss black cumin).
Medina-Caliz I, Garcia-Cortes M, Gonzalez-Jimenez A, Cabello MR, Robles-Diaz M, Sanabria-Cabrera J, Sanjuan-Jimenez R, et al., Spanish DILI Registry. (2018). Herbal and dietary supplement-induced liver injuries in the Spanish DILI Registry. Clin Gastroenterol Hepatol. (Among 856 cases of hepatotoxicity enrolled in the Spanish DILI Registry between 1994 and 2016, 32 were attributed to herbal products, the most frequent cause being green tea [n=8] and Herbalife products [n=6], no mention of black cumin).
Khonche A, Huseini HF, Gholamian M, Mohtashami R, Nabati F, Kianbakht S. (2019). Standardized Nigella sativa seed oil ameliorates hepatic steatosis, aminotransferase and lipid levels in non-alcoholic fatty liver disease: A randomized, double-blind and placebo-controlled clinical trial. J Ethnopharmacol. (Among 120 Iranian adults with nonalcoholic fatty liver disease treated with black cumin or a placebo oil twice daily for 3 months, the decrease in ultrasound hepatic steatosis scores was greater in the black cumin than placebo groups as were changes in serum ALT [-29 vs -12 U/L], cholesterol [-14 vs -9 mg/dL] and triglyceride levels [-10 vs -0.2 mg/dL], while patients “did not report any adverse drug effect”).
Darand M, Darabi Z, Yari Z, Saadati S, Hedayati M, Khoncheh A, Hosseini-Ahangar B, et al. (2019). Nigella sativa and inflammatory biomarkers in patients with non-alcoholic fatty liver disease: results from a randomized, double-blind, placebo-controlled, clinical trial. Complement Ther Med. (Among 50 adults with nonalcoholic fatty liver disease treated with black cumin powdered extract [2 gm daily] vs placebo for 12 weeks, changes in serum aminotransferases were similar in the two groups while the change in hepatic steatosis was greater with black cumin, but the differences were not statistically significant).
Azizi N, Amini MR, Djafarian K, Shab-Bidar S. (2021). The effects of Nigella sativa supplementation on liver enzymes levels: a systematic review and meta-analysis of randomized controlled trials. Clin Nutr Res. (Systematic review of randomized controlled trials of black cumin vs placebo identified 8 published studies [n=560 patients] that included serum aminotransferase levels, found a found difference in the weighted mean change in ALT levels of -7 U/L and AST of -8.1 U/L with black cumin vs placebo).
Hossain MS, Sharfaraz A, Dutta A, Ahsan A, Masud MA, Ahmed IA, Goh BH, et al. (2021). A review of ethnobotany, phytochemistry, antimicrobial pharmacology and toxicology of Nigella sativa L. Biomed Pharmacother. (Review of the phytochemistry and antimicrobial activities of black cumin seeds; thymoquinone, the major volatile oil of cumin seeds, showed no evidence of hepatotoxicity in several animal species even when given in high doses).
Hannan MA, Rahman MA, Sohag AAM, Uddin MJ, Dash R, Sikder MH, Rahman MS, et al. (2021). Black Cumin (Nigella sativa L.): a comprehensive review on phytochemistry, health benefits, molecular pharmacology, and safety. Nutrients. (An extensive review of the phytochemistry of black cumin and its use in traditional medicine for a wide array of diseases and conditions, toxicity studies have shown that thymoquinone toxicity occurs only with very high doses [above 500 mg/kg] when given orally).
Shoaei-Hagh P, Kamelan Kafi F, Najafi S, Zamanzadeh M, Heidari Bakavoli A, Ramezani J, Soltanian S, et al. (2021). A randomized, double-blind, placebo-controlled, clinical trial to evaluate the benefits of Nigella sativa seeds oil in reducing cardiovascular risks in hypertensive patients. Phytother Res. (Among 60 Iranian adults with hypertension treated with black cumin oil vs sunflower oil twice daily for 8 weeks, systolic and diastolic blood pressure decreased more with black cumin [-8 and -6.5 vs -3 and -1 mm/Hg], as did fasting blood glucose [-6.5 vs +4.0 mg/dL] and LDL cholesterol levels [-14 vs -4 mg/dL], and while 20% of patients on black cumin oil had mild gastrointestinal side effects, there were no changes in serum ALT, AST or alkaline phosphatase levels).
Ballotin VR, Bigarella LG, Brandão ABM, Balbinot RA, Balbinot SS, Soldera J. (2021). Herb-induced liver injury: Systematic review and meta-analysis. World J Clin Cases. (Systematic review of the literature on herb induced liver injury identified 446 references describing 936 cases due to 79 different herbal products, the most common being He Shou Wu [91], green tea [90] Herbalife products [64], kava kava [62] and greater celandine [48]; black cumin was not listed among the 79 implicated products).
Bessone F, García-Cortés M, Medina-Caliz I, Hernandez N, Parana R, Mendizabal M, Schinoni MI, et al. (2022). Herbal and dietary supplements-induced liver injury in Latin America: experience from the LATINDILI Network. Clin Gastroenterol Hepatol. (Among 367 cases of hepatotoxicity enrolled in the Latin American DILI Network between 2011 and 2019, 29 [8%] were attributed to herbal products, the most frequent being green tea [n=7], Herbalife products [n=5] and garcinia [n=3], while black cumin is not mentioned).
Thomas JV, Mohan ME, Prabhakaran P, Das S S, Maliakel B. (2022). I M K. A phase I clinical trial to evaluate the safety of thymoquinone-rich black cumin oil (BlaQmax®) on healthy subjects: Randomized, double-blinded, placebo-controlled prospective study. Toxicol Rep. (Among 70 healthy adults treated with a black cumin oil product [200 mg, 5% thymoquinone] or placebo daily for 9 days, LDL cholesterol and triglycerides decreased with therapy, and there were no serious adverse events and only mild gastrointestinal upset with cumin oil [bloating, diarrhea, and dysgeusia], and serum ALT, AST and Alk P levels did not change).
Adam SH, Mohd Nasri N, Kashim MIAM, Abd Latib EH, Ahmad Juhari MAA, Mokhtar MH. (2022). Potential health benefits of Nigella sativa on diabetes mellitus and its complications: a review from laboratory studies to clinical trials. Front Nutr. (Review of the potential efficacy of black cumin in type 2 diabetes which rests upon data from in vitro and in vivo studies and in small, short term human trials assessing the effects of various oral black cumin preparations on fasting blood glucose and hemoglobin A1c levels; most studies reporting no adverse events, no effects on serum enzyme levels, and no instances of liver injury).
Assaad-Khalil S, Elkafrawy N, Khaled M, Mogeib O, Badr H, Rashwan A, Youssef M, et al. (2022). A phase II, randomized, double-blind, double-dummy, active-controlled clinical trial to investigate the efficacy and safety of NW Low-Glu® in patients newly diagnosed with type 2 diabetes mellitus. Evid Based Complement Alternat Med. (Among 232 adults with newly diagnosed type 2 diabetes treated with 2 or 4 tablets of a combination herbal product [Ficus deltoidei, Cinnamomum cassia and Nigella sativa 250 mg] vs metformin [1000 mg] daily for 90 days, decreases in mean hemoglobin A1c and 2 hour postprandial glucose levels decreased to a similar extend in all 3 arms, while adverse events were more frequent with the herbal product, but there were no severe adverse events or liver related side effects).
Huseini HF, Mohtashami R, Sadeghzadeh E, Shadmanfar S, Hashem-Dabaghian F, Kianbakht S. (2022). Efficacy and safety of oral Nigella sativa oil for symptomatic treatment of knee osteoarthritis: A double-blind, randomized, placebo-controlled clinical trial. Complement Ther Clin Pract. (Among 116 Iranian adults with knee osteoarthritis treated with black cumin seed oil [2.5 mg of thymoquinone] or placebo every 8 hours for 30 days, knee pain, stiffness and function improved with the black seed oil and there were no changes in serum levels of ALT, AST or Alk P, and “no side effect was observed” in either group).
Mohtashamian A, Ebrahimzadeh A, Shamekhi Z, Sharifi N. (2023). Nigella sativa supplementation and non-alcoholic fatty liver disease: a systematic review of clinical trials. Avicenna J Phytomed. (Systematic review identified four randomized controlled trials of cumin oil vs placebo in a total of 324 patients [3 from Iran, 1 Pakistan] with nonalcoholic steatohepatitis, 3 of which demonstrated a reduction in hepatic steatosis and 3 a decrease in ALT and AST levels; no mention of adverse events).

## OTHER REFERENCE LINKS

1 Recent References on Black Cumin: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Black+Cumin+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Black Cumin: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Black%20Cumin)